# Amoxicillin

## OVERVIEW

Amoxicillin is considered a third generation or aminopenicillin and is one of the most commonly prescribed antibiotics. Amoxicillin and other aminopenicillins have been linked with idiosyncratic liver injury, but only rarely and in isolated case reports.

### Background

Amoxicillin (a mox' i sil' in) is an orally available aminopenicillin antibiotic that has been available in the United States since 1980, for which currently more than 20 million prescriptions are filled yearly. Amoxicillin is used to treat mild to moderate infections caused by susceptible agents, such as (but not limited to) Escherichia coli, Hemophilus influenzae, Listeria monocytogenesis, Neisseria gonorrhoeae, Proteus mirabilis, Salmonella, Shigella, Staphylococcus aureus (non-penicillinase producing), Staphylococcus epidermidis, and Streptococcus pneumoniae. Amoxicillin is available in multiple generic formulations as tablets or capsules of 250, 500 and 875 mg and is usually given in doses of 250 to 850 mg every 8 hours for 7 to 14 days. Pediatric formulations in liquid suspension and chewable tablets are also available. Side effects are generally mild and self-limited and can include diarrhea, nausea and vomiting, fatigue, headache, local reactions and rash. Rare but potentially serious adverse events include hypersensitivity reactions, anaphylaxis, severe skin rash, Stevens Johnson syndrome, C. difficile diarrhea, neutropenia, aplastic anemia and thrombocytopenic purpura.

### Hepatotoxicity

Rare instances of idiosyncratic liver injury have been reported in persons receiving the aminopenicillins including amoxicillin. Cases are characterized by a short latency period of a few days to as long as two weeks. The onset of liver injury can occur after the antibiotic is stopped. The serum enzyme pattern associated with aminopenicillin liver injury has included a hepatocellular pattern with marked elevations in ALT and AST, and minimal elevations in alkaline phosphatase and rapid recovery after withdrawal. In addition, cholestatic forms of hepatic injury with marked alkaline phosphatase elevations (as also seen with penicillin-induced liver injury) have also been described, some of which have been associated with prolonged cholestasis (Case 1). The onset of hepatic injury may be accompanied by signs or symptoms of hypersensitivity such as eosinophilia, rash and arthralgias, and in some cases is accompanied by toxic epidermal necrolysis or Stevens Johnson syndrome.

Much more common than liver injury from amoxicillin alone is the typically cholestatic hepatitis that occurs after treatment with the combination of amoxicillin and clavulanate. Indeed, this combination is currently the most common cause of idiosyncratic acute liver injury in the United States, Europe and Australia. The injury, however, is usually attributed to the clavulanate rather than amoxicillin. The clinical features are similar but perhaps not completely the same. In cases of liver injury seeming due to amoxicillin, an extra effort should be made to make sure that it was not amoxicillin-clavulanate [Augmentin] that was taken.

Likelihood score: B (highly likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury associated with amoxicillin use is probably hypersensitivity or allergy. Recurrence with reexposure has been described as well as cross sensitivity to hepatic injury with other penicillins and cephalosporins.

### Outcome and Management

In the few cases that have been described, the majority of patients have recovered, although recovery has been slow in some cholestatic instances (2 to 6 months). Rare instances of acute liver failure and several cases of vanishing bile duct syndrome have been reported with aminopenicillin induced liver injury. Corticosteroids have often been used to treat the allergic manifestations of penicillin related immunoallergic hepatitis; while corticosteroid therapy may improve fever and rash promptly, their efficacy in ameliorating the accompanying liver disease has not been shown. Instances of recurrence of liver injury with unintentional reexposure to aminopenicillins and recurrence with exposure to cephalosporins have been reported. Patients with aminopenicillin induced hepatitis should avoid reexposure to other penicillins and should take cephalosporins with caution.

Drug Class: Antiinfective Agents, Aminopenicillins

Other Drugs in the Subclass, Aminopenicillins: Amoxicillin-Clavulanate, Ampicillin, Ampicillin-Sulbactam, Bacampicillin, Pivampicillin

## CASE REPORT

### Case 1. Cholestatic hepatitis due to amoxicillin therapy.(1)

A 24 year old woman developed anorexia and weakness followed by dark urine and itching 5 days into a 10 day course of amoxicillin for pharyngitis and fever. Within days of finishing the 10 day course, a friend told her that she looked jaundiced. Ten days after stopping the antibiotic, she sought medical care for continuing jaundice and pruritus. Serum ALT, AST and alkaline phosphatase were only modestly elevated, but total serum bilirubin was 10.5 mg/dL with a direct fraction of 8.0 mg/dL. There was no eosinophilia, rash or fever. Tests for viral hepatitis and autoantibodies were negative. An ultrasound of the liver was normal. Her jaundice deepened, and she underwent endoscopic retrograde pancreato-cholangiography (ERCP) which was also normal. A liver biopsy showed intrahepatic cholestasis, mild portal inflammation, but little hepatocellular injury, compatible with a resolving cholestatic hepatitis secondary to a medication. She had taken no other medications, herbals or over-the-counter products and had no previous history of liver disease or alcohol abuse.

#### Key Points

Medication: | Amoxicillin (1500 mg daily for 10 days)
Pattern: | Cholestatic (R=1.2)
Severity: | 3+ (jaundice and hospitalization)
Latency: | Five days
Recovery: | Two months
Other medications: | None

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
| | Amoxicillin 1500 mg/day for 10 days for pharyngitis
20 | 10 | 30 | 314 | 10.5 | AMA, ANA, pANCA negative
28 | 18 | 13 | 383 | 18.4 | US normal
51 | 41 | 39 | 546 | 23.3 | ERCP normal
58 | 48 | 13 | 476 | 4.0 | Liver biopsy
82 | 72 | 12 | 222 | 0.7
Normal Values | | <18 | <240 | <1.2

#### Comment

A dramatic example of somewhat prolonged cholestatic liver injury starting after a few days of amoxicillin therapy. The short latency, abrupt onset and cholestatic pattern of enzymes and clinical presentation are compatible with penicillin and aminopenicillin induced hepatic injury. Cases such as this are convincing, but extremely rare given the frequency with which amoxicillin is used. Patients with suspected amoxicillin induced liver injury should be questioned carefully about the antibiotic taken, making sure that it was not amoxicillin-clavulanate instead (a much more common cause of cholestatic liver injury). This patient should be cautioned against future exposure to penicillins.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amoxicillin – Generic, Amoxil®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=amoxicillin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Amoxicillin | 26787-78-0 | C16-H19-N3-O5-S

## CITED REFERENCE

1 Bolzan H, Spatola J, Castelletto R, Curciarello J. Colestasis intrahepática inducida por amoxicilina sola [Intrahepatic cholestasis induced by amoxicillin alone]. Gastroenterol Hepatol 2000; 23: 237-9. Spanish. 10902278

## ANNOTATED BIBLIOGRAPHY

References updated: 24 January 2026

Zimmerman HJ. Penicillins. In, Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott Williams and Wilkins, 1999. p. 595-6. (Expert review of penicillins and liver injury published in 1999; the penicillins commonly lead to hypersensitivity reactions but rarely to liver injury).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics mentions that penicillins rarely cause liver injury and both hepatocellular and cholestatic patterns of injury have been described).
MacDougall C. Penicillins, cephalosporins, and other β-lactam antibiotics. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1023-38. (Textbook of pharmacology and therapeutics).
Davies MH, Harrison RF, Elias E, Hübscher SG. Antibiotic-associated acute vanishing bile duct syndrome: a pattern associated with severe, prolonged, intrahepatic cholestasis. J Hepatol 1994; 20: 112-6. (Two cases of vanishing bile duct syndrome, one with toxic epidermolysis developing in a 37 year old woman a day after starting amoxicillin with persistent sclerosing cholangitis-like syndrome and severe jaundice documented by four liver biopsies; second case in a 42 year old woman treated with flucloxacillin who developed cholestatic hepatitis followed by persistent Alk P elevations who underwent five liver biopsies). 8201211
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports identified 943 liver injuries over 21 years in New Zealand; amoxicillin is listed in top 20 drugs over several periods). 8816722
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports in Denmark from 1978 to 1987; no mention of aminopenicillins). 1506809
Bolzan H, Spatola J, Castelletto R, Curciarello J. Colestasis intrahepática inducida por amoxicilina sola [Intrahepatic cholestasis induced by amoxicillin alone]. Gastroenterol Hepatol 2000; 23: 237-9. Spanish. (24 year old woman developed weakness after 5 days and dark urine after 7 days of amoxicillin therapy, but continued it for 10 days developing deep jaundice and pruritus [bilirubin 10.5 rising to 23.3 mg/dL, ALT 30 U/L, Alk P 314-546 U/L], resolving within 2 months of stopping: Case 1). 10902278
Schwarze C, Schmitz V, Fischer HP, Sauerbruch T, Spengler U. Vanishing bile duct syndrome associated with elevated pancreatic enzymes after short-term administration of amoxicillin. Eur J Gastroenterol Hepatol 2002; 14: 1275-7. (45 year old woman developed progressive cholestasis and vanishing bile duct syndrome 2 months after a 6 day course of amoxicillin; progressive cholestasis evolved into chronic liver failure and death 18 months later). 12439126
Heluwaert F, Roblin X, Duffournet V, Capony P, Martin D, Roblin X. [Hepatitis related to amoxicillin or levofloxacin: a case report] Rev Med Interne 2003; 24: 841-3. French. (34 year old woman developed nausea followed by jaundice 2 weeks after starting 6 day course of amoxicillin and 1 week after starting a 5 day course of levofloxacillin [bilirubin 6.6 rising to 12.6 mg/dL, ALT 8.7 times and Alk P 2.1 times ULN]; case most compatible with levofloxacin hepatotoxicity with abrupt onset and hepatocellular pattern of serum enzymes). 14656650
Romney R, Biour M, Belloula D, Elbaz D, Carriere J, Cadranel JF. [Amoxicillin induced acute hepatitis] Gastroenterol Clin Biol 2004; 28: 505-6. French. (27 year old developed acute hepatitis 3 days after starting amoxicillin [bilirubin 7.9 mg/dL, ALT 84 times, Alk P normal], resolving within 1 month; patient also took acetaminophen). 15243334
de Abajo FJ, Montero D, Madurga M, Rodriguez LAG. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Brit J Clin Pharm 2004; 58: 71-80. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury [2.4/100,000 person-years]; amoxicillin was associated with a minimal increase in risk). 15206996
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure; one case was attributed to amoxicillin-clavulanate, but none to penicillin, ampicillin or amoxicillin alone). 15390328
Fontana RJ, Shakil AO, Greenson JK, Boyd I, Lee WM. Acute liver failure due to amoxicillin and amoxicillin-clavulanate. Dig Dis Sci 2005; 50: 1785-90. (Two case reports, one of acute liver failure arising 1 month after 6 day course of oral amoxicillin for dental work [bilirubin 23.0 mg/dL, ALT 521 U/L, GGT 89 U/L], progressing to liver failure and liver transplant; second case attributed to amoxicillin-clavulanate). 16187174
Andrade RJ, Lucena MI, Kaplowitz N, Garcia-Munoz B, Borraz Y, Pachkoria K, Garcia-Cortes M, et al. Outcome of acute idiosyncratic drug-induced liver injury: Long-term follow-up in a hepatotoxicity registry. Hepatology 2006; 44: 1581-8. (Clinical description of 28 patients with “chronic” outcome of drug induced liver injury included one case attributed to amoxicillin with jaundice arising 5 days after a 1 day course with severe hypersensitivity; 6 months later, only evidence of chronic injury was an elevated GGT ~1.4 times ULN). 17133470
Madroñero AB, Porcel JM, Bielsa S. [Hepatotoxicity induced by amoxicillin] Rev Esp Enferm Dig 2007; 99: 173-4. Spanish. (76 year old woman developed acute cholestatic hepatitis 2 weeks after starting 6 days of amoxicillin [bilirubin 9.4 mg/dL, ALT 54 U/L, Alk P 339 U/L], resolving within 1 month of stopping). 17516833
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 23 cases were attributed to amoxicillin-clavulanate, 2 cases to amoxicillin, but none to ampicillin). 18955056
Treudler R, Grunewald S, Gebhardt C, Simon JC. Prolonged course of acute generalized exanthematous pustulosis with liver involvement due to sensitization to amoxicillin and paracetamol. Acta Derm Venereol 2009; 89: 314-5. (48 year old man treated with amoxicillin for 3 days and acetaminophen for 5 days developed generalized pustular rash with fever and later had ALT elevations [3 times ULN] and hepatomegaly that arose after initiation of high dose methylprednisolone therapy). 19479138
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; 3 [1%] were attributed to the combination of amoxicillin and clavulanate, but none were attributed to ampicillin or amoxicillin alone]. 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 66 due to antimicrobial agents, including two attributed to amoxicillin but none to ampicillin; no details given). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, amoxicillin-clavulanate accounted for 38 cases [0.4%] for an adjusted odds ratio of 1.7, whereas neither amoxicillin or ampicillin alone were listed among the 41 most common causes [linked to at least 30 cases]). 21039766
Kim JS, Jang YR, Lee JW, Kim JY, Jung YK, Chung DH, Kwon OS, Kim YS, Choi DJ, Kim JH. A case of amoxicillin-induced hepatocellular liver injury with bile-duct damage. Korean J Hepatol 2011; 17: 229-32. (39 year old woman developed liver injury 8 weeks after starting amoxicillin [2 g daily] for actinomycosis [bilirubin rising to 2.9 mg/dL, ALT 157-216 U/L, Alk P 100-199 U/L], liver biopsy showing bile duct damage and loss, and persistence of mild liver test abnormalities during follow up). 22102391
Ruiz Rebollo ML, Aller De La Fuente R, Macho Conesa A, Salado Valdivieso I, Sainz Gil M, Carvajal A, Manuel González J. [Amoxicillin-induced cholestatic hepatitis]. Gastroenterol Hepatol 2011; 34: 474-7. Spanish. (87 year old man developed jaundice 2 weeks after a 10 day course of amoxicillin [bilirubin 15.5 mg/dL, ALT 292 U/L, Alk P 295 U/L], resolving within 2 months of presentation). 21783281
Chaabane NB, Safer L, Njim L, Zakhama A, Saffar H. Cholestatic hepatitis related to amoxicillin. Drug Chem Toxicol 2011; 34: 357-8. (34 year old woman developed pruritis followed by jaundice 1 week after stopping a 10 day course of amoxicillin [bilirubin 30.5 mg/dL, ALT 56 U/L, Alk P 647 U/L], resolving within 8 weeks, but redeveloping jaundice after a 3 day course of amoxicillin 6 months later ). 21714770
Oxlund J, Ferguson AH. [Amoxicillin-induced hepatitis]. Ugeskr Laeger 2011; 173: 1885-6. Danish. (61 year old man developed jaundice 20 days after starting amoxicillin without clavulanate [bilirubin 5.6 mg/dL, ALT 709 U/L, Alk P 316 U/L], resolving within 4 weeks of stopping). 21712012
Lucena MI, Molokhia M, Shen Y, Urban TJ, Aithal GP, Andrade RJ, Day CP, et al.; Spanish DILI Registry; EUDRAGENE; DILIN; DILIGEN; International SAEC. Susceptibility to amoxicillin-clavulanate-induced liver injury is influenced by multiple HLA class I and II alleles. Gastroenterology 2011; 141: 338-47. (A genome wide association study [GWAS] on 201 European and U.S. cases of amoxicillin-clavulanate hepatotoxicity and 532 population controls identified two strong HLA associations, one in the class II [DRB1*1501-DQB1*0602] and one in the class I region [A*0201]). 21570397
Bollaert M, Jeulin H, Waton J, Gastin I, Tréchot P, Rabaud C, Schmutz JL, Barbaud A. [Six cases of spring DRESS]. Ann Dermatol Venereol 2012; 139: 15-22. (Among 6 patients who developed DRESS syndrome and presented to a single medical center within a one month period, all had herpes virus in blood [EBV, HSV, or HHV-6] and had received medications starting within 3-6 weeks of onset including one case each attributed amoxicillin, allopurinol, carbamazepine and TMP/SMZ, and another 2 cases associated with multiple agents including vancomycin). 22225738
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, the most commonly implicated agent being amoxicillin with clavulanate [15 cases]; none were attributed to amoxicillin alone or ampicillin). 23419359
Sistanizad M, Peterson GM. Drug-induced liver injury in the Australian setting. J Clin Pharm Ther 2013; 38: 115-20. (Among 17 cases of suspected drug induced liver injury seen at a single referral hospital in Tasmania over a 12 month period, 11 were due to antibiotics including flucloxacillin in 4, amoxicillin in 2, amoxicillin-clavulanate in 2, and rifampin, moxifloxacin and ciprofloxacin in 1 each). 23350857
Girelli F, Bernardi S, Gardelli L, Bassi B, Parente G, Dubini A, Serra L, Nizzoli M. A new case of DRESS syndrome induced by sulfasalazine and triggered by amoxicillin. Case Rep Rheumatol 2013; 2013: 409152. (53 year old woman with uveitis developed sore throat, fever and lymphadenopathy 6 weeks after starting sulfasalazine which was treated with amoxicillin-clavulanate whereupon she developed worsening fever, rash and was found to have liver injury [bilirubin 2.7 mg/dL, ALT 350 U/L, Alk P 2959 U/L, INR normal], responding to methylprednisolone and stopping drugs; role of amoxicillin-clavulanate being uncertain in this onset of DRESS syndrome with sulfasalazine therapy). 23936716
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Giaquinto C, Picelli G, Oteri A, et al. Idiopathic acute liver injury in paediatric outpatients: incidence and signal detection in two European countries. Drug Saf 2013; 36: 1007-16. (Analysis of 3 electronic healthcare databases from Italy and the Netherlands from 2000-2008 identified 785 cases of unexplained acute liver injury in children, linked to 110 possible medications, with increased adjusted relative risk [RR] of recent exposure to amoxicillin-clavulanate [RR=18.6] and amoxicillin [RR=7.5]). 23591830
Kaye JA, Castellsague J, Bui CL, Calingaert B, McQuay LJ, Riera-Guardia N, Saltus CW, et al. Risk of acute liver injury associated with the use of moxifloxacin and other oral antimicrobials: a retrospective, population-based cohort study. Pharmacotherapy 2014; 34: 336-49. (In a US healthcare database with 1.3 million antimicrobial users, there were 607 cases of liver injury and 11 cases of liver failure, the highest relative risk for current single use being 3.2 for levofloxacin, 2.5 for amoxicillin-clavulanate, 2.5 for doxycycline, 2.3 for moxifloxacin and 2.3 for amoxicillin). 24865821
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, of which 37 [19%] were attributed to antimicrobials, including one to benzathine penicillin and 3 to amoxicillin-clavulanate, but none to amoxicillin alone or to 2nd or 4th generation penicillins). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics of which 106 [12%] were due to penicillins including one to 1st, three to 2nd [all due to oxacillin], 97 to 3rd [91 to amoxicillin-clavulanate, and 6 to amoxicillin alone] and five to 4th generation penicillins [all 5 to piperacillin/tazobactam]). 25754159
Guéant JL, Romano A, Cornejo-Garcia JA, Oussalah A, Chery C, Blanca-López N, Guéant-Rodriguez RM, et al. HLA-DRA variants predict penicillin allergy in genome-wide fine-mapping genotyping. J Allergy Clin Immunol 2015; 135: 253-9. (In a genome wide association study of 387 patients with immediate allergic reactions to beta-lactam antibiotics, several class 2 HLA associations [HLA-DRA regions] were found for penicillin responses, but they did not apply to cephalosporin cases). 25224099
Björnsson ES. Hepatotoxicity by drugs: the most common implicated agents. Int J Mol Sci 2016; 17: 224. (Review of the most common causes of drug induced liver injury based upon categorization from LiverTox, amoxicillin-clavulanate but not other forms of penicillin were in the top category of causes of liver injury [likelihood scores of A, with more than 100 cases published in the literature]). 26861310
Nicoletti P, Aithal GP, Björnsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al.; International Drug-Induced Liver Injury Consortium, Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. Association of liver injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology 2017; 152: 1078-89. (A genome wide association study done on 862 Caucasian patients with drug induced liver injury demonstrated a strong link with HLA-A*33:01 in those with cholestatic liver injury, particularly in cases attributed to terbinafine, fenofibrate and ticlopidine). 28043905
Blumenthal KG, Youngster I, Rabideau DJ, Parker RA, Manning KS, Walensky RP, Nelson SB. Peripheral blood eosinophilia and hypersensitivity reactions among patients receiving outpatient parenteral antibiotics. J Allergy Clin Immunol 2015; 136: 1288-94.e1. (Among 824 patients who underwent outpatient parenteral antibiotic therapy for at least 2 weeks, 210 [25%] developed eosinophilia including 58 of 207 [28%] who received “penicillins” of whom 3 developed signs of “possible” DRESS syndrome; specific penicillins accounting for the cases were not provided). 25981739
Tailor A, Faulkner L, Naisbitt DJ, Park BK. The chemical, genetic and immunological basis of idiosyncratic drug-induced liver injury. Hum Exp Toxicol 2015; 34: 1310-7. (Review of mechanisms of idiosyncratic drug induced liver injury focusing upon chemically reactive drug metabolites and genetic associations, particularly those with HLA alleles that implicate the adaptive immune response). 26614821
Munz M, Grummich H, Birkmann J, Wilhelm M, Holzgrabe U, Sörgel F. Severe drug-Induced liver injury as an adverse drug event of antibiotics: a case report and review of the literature. Chemotherapy 2017; 62: 367-73. (20 year old woman received 4 antibiotics [amoxicillin, ciprofloxacin, cefazolin and clindamycin] and acetaminophen within weeks of developing rash, fever and jaundice [bilirubin 3.7 mg/dL, ALT 1219 U/L, Alk P 143 U/L, GGT 201 U/L, INR 1.6], with worsening and signs of hepatic failure but subsequent spontaneous and complete resolution, the specific cause being obscure because of the many drug exposures). 28934748
Takeuchi Y, Shinozaki T, Kumamaru H, Hiramatsu T, Matsuyama Y. Analyzing intent-to-treat and per-protocol effects on safety outcomes using a medical information database: an application to the risk assessment of antibiotic-induced liver injury. Expert Opin Drug Saf 2018; 17: 1071-9. (Cohort matching of cases with vs without antibiotic therapy in a large electronic medical record database from the University of Tokyo Hospital from 2011 to 2015 with adjustments found rates of liver test abnormalities within 30 days of starting penicillins [25.2 per 1000] was higher than that of fluoroquinolones [11.4] and macrolide antibiotics [8.1] as well as controls [6.5 to 7.1]). 30252549
Cirulli ET, Nicoletti P, Abramson K, Andrade RJ, Björnsson ES, Chalasani N, Fontana RJ, et al.; Drug-Induced Liver Injury Network (DILIN) investigators; International DILI consortium (iDILIC). A missense variant in PTPN22 is a risk factor for drug-induced liver injury. Gastroenterology 2019; 156: 1707-16.e2. (Genome wide association studies on 2048 patients with drug induced liver injury and 12,439 controls identified a variant in PTPN22 which was highly associated with liver injury, allele frequency being 0.12 among cases and 0.08 among controls with highest association in Northern Europeans and in cases of amoxicillin-clavulanate, PTPN22 being a cellular kinase involved in modulation of immune reactions). 30664875
Li L, Zheng S, Chen Y. Stevens-Johnson syndrome and acute vanishing bile duct syndrome after the use of amoxicillin and naproxen in a child. J Int Med Res 2019; 47: 4537-43. (6 year old boy developed rash and jaundice shortly after receiving amoxicillin and naproxen [bilirubin 3.1 mg/dL, ALT 942 U/L, Alk P 318 U/L, GGT 150 U/L, INR 1.1], with progression of rash to Stevens Johnson syndrome requiring high dose corticosteroid therapy and worsening of liver disease [peak bilirubin 20.4 mg/dL, peak GGT 981 U/L], which persisted for 4 months but eventually resolved although Alk P and GGT remained slightly abnormal at 6 months). 31448655
Zhang Y, Shi D, Abagyan R, Dai W, Dong M. Population scale retrospective analysis reveals potential risk of cholestasis in pregnant women taking omeprazole, lansoprazole, and amoxicillin. Interdiscip Sci. 2019;11:273-281.. (Analysis of reports to the FDA’s Adverse Event Reporting System between 2004 and 2017 found linkage of use of amoxicillin with excess reports of cholestasis which was particular associated with concurrent pregnancy). 31106388
Schosheim A, Mockler D, Chawla A. Does genetics play a role in acute liver injury after amoxicillin exposure? ACG Case Rep J. 2020;7: (Two sisters, ages 1 and 3 years, developed jaundice shortly after receiving a courses of oral amoxicillin-clavulanate and amoxicillin [bilirubin 6.4 and 6.7 mg/dL, ALT 4343 and 2667 U/L, GGT 151 U/L and Alk P 578 U/L, suggesting that genetic factors contribute to risk of liver injury after amoxicillin and amoxicillin-clavulanate). 33062772
Tailor A, Meng X, Adair K, Farrell J, Waddington JC, Daly A, Pirmohamed M, et al. HLA DRB1*15:01-DQB1*06:02-restricted human CD4+ T cells are selectively activated with amoxicillin-peptide adducts. Toxicol Sci. 2020;178:115-126. (Amoxicillin modified peptides bound to and activated DRB1*1501-DQB1*06:02 restricted human CD4+ T cells while amoxicillin and unmodified peptides had no effect). 32777075
Ortland I, Mirjalili M, Kullak-Ublick GA, Peymani P. Drug-induced liver injury in Switzerland: an analysis of drug-related hepatic disorders in the WHO pharmacovigilance database VigiBase™ from 2010 to 2020. Swiss Med Wkly. 2021;151:w20503. (Among 2042 reports of severe drug-induced liver injury reported between 2010 and 2020 from Switzerland to the global ViviBase database, the most commonly implicated agents were acetaminophen [12%], amoxicillin-clavulanate [7%], esomeprazole [4%], atorvastatin [4%], ibuprofen [3%] and check point inhibitors [6%]). 34000058
Guo YM, Ge FL, Song HB, Xiong P, Jing J, Niu M, Zhao X, et al. Relative risk analysis of liver-related adverse drug reactions in children based on China's National Spontaneous Reporting System. J Pediatr. 2021;234:85-91. (Among 1206 pediatric liver related adverse events reported to the China National Spontaneous Reporting System, the most frequently implicated agents were azithromycin, methotrexate, anti-tuberculosis agents, meropenem, and vancomycin, amoxicillin accounted for 14 cases [1%]). 33794217
Nicoletti P, Dellinger A, Li YJ, Barnhart HX, Chalasani N, Fontana RJ, Odin JA, et al; Drug-Induced Liver Injury Network (DILIN); International Drug-Induced Liver Injury Consortium (iDILIC); Prospective European Drug-Induced Liver Injury (Pro-Euro DILI) Investigators. Identification of reduced ERAP2 expression and a novel HLA allele as components of a risk score for susceptibility to liver injury due to amoxicillin-clavulanate. Gastroenterology. 2023;164:454-466. (Genome and transcriptome wide association studies on 444 patients with liver injury from amoxicillin-clavulanate vs 10,397 controls identified 3 HLA region risk alleles [A*02:01, B*14:01, and DRB1*15:01], and 2 non-HLA risk variants [in ERAP2 and PTPN22] but only A*02:01 [AF 0.35 vs 0.28] and ERAP2 were found to be risk alleles for amoxicillin liver injury). 36496055
Gu S, Rajendiran G, Forest K, Tran TC, Denny JC, Larson EA, Wilke RA. Drug-induced liver injury with commonly used antibiotics in the All of Us Research Program. Clin Pharmacol Ther. 2023;114:404-412. (Among 41,982 patients enrolled in a prospective study of genetics and health who had been exposed to amoxicillin, electronic medical records identified 22 as developing drug-induced liver injury for an estimated rate of 1:1,920 exposed). 37150941
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications, estimating the incidence for amoxicillin injury to be 1.9 events per 10,000 person-years, approximately one-third the rate for amoxicillin-clavulanate [~1:5000 exposed]). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, only 2 [0.5%] were attributed to amoxicillin, the 40th most frequently implicated agent). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 15 cases [1%] attributed to amoxicillin, at an estimated rate of 1 per 170,000 persons exposed, a rate almost ten-fold less than amoxicillin-clavulanate [1 per 2,400 persons).
Björnsson RA, Sigurdsson SS, Arnarson DT, Logason E, Björnsson ES. The frequency of drug-induced liver injury due to antibiotics among hospitalised patients. Drug Saf. 2025;48:795-804.. (Among 2292 patients treated with the 14 most used antibiotics while hospitalized in a single Icelandic referral center between 2012-2023, 52 developed drug-induced liver injury, but none were due to amoxicillin despite 3,922 having been exposed). 40072769
Maris BR, Grama A, Pop TL. Drug-induced liver injury-pharmacological spectrum among children. Int J Mol Sci. 2025;26:2006.. (Review of drug-induced liver injury in children mentions that amoxicillin-clavulanate is the most frequently implicated agent but few cases have been reported due to amoxicillin or other aminopenicillins). 40076629
Rahnama-Moghadam S, Arora N, Vuppalanchi R, Li YJ, Gu J, Barnhart H, Phillips E, Chalasani N; Drug Induced Liver Injury Network. DRESS syndrome in patients with drug-induced liver injury: characteristics and high-risk factors. Am J Gastroenterol. 2025 Jun 12:10. Epub ahead of print.. (Among 2121 patients with suspected drug-induced liver injury enrolled in a prospective US registry between 2004 and 2023, 19 were attributed to amoxicillin including [5%] with DRESS syndrome, and another 6 [32%] had rash without DRESS). 40504263

## OTHER REFERENCE LINKS

1. Recent References on Amoxicillin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(amoxicillin/AE+NOT+clavulanic+acid)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Amoxicillin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=amoxicillin)